# Horse Chestnut

## OVERVIEW

### Introduction

Horse chestnut is an herb prepared from the leaves or seeds of the Horse chestnut tree (Aesculus hippocastanum), and is used primarily for complications of venous insufficiency including varicose veins, ankle swelling, and leg cramps. Horse chestnut has been implicated in rare instances of clinically apparent liver injury.

### Background

The horse chestnut tree is native to Persia and Eastern Asia, but has been introduced worldwide and is widely planted for its handsome shape and attractive leaves, nuts and flowers. The horse chestnut should not be confused with the California or Ohio chestnuts (Aesculus california and glabra), which are different species and more often called buckeye trees. Horse chestnut extract is used for the treatment of symptoms of varicose veins, hemorrhoids and phlebitis. Extracts of the horse chestnut seeds are also used for diarrhea, fever and urinary hesitancy. Creams with horse chestnut extract are used topically for muscle and joint aches due to arthritis or trauma. The constituents of horse chestnut extracts are many and include triterpene saponins, hydroxycoumarins, flavonoids, and tannins. Importantly, horse chestnut seeds contain the toxic triterpene saponin known as escin and its glycoside esculin. Commercial preparations remove the toxic saponins and are generally well tolerated. Horse chestnut is available as capsules, tablets, liquid extract, gels and solutions for parenteral administration. Side effects include nausea, dizziness, headache and pruritus.

### Hepatotoxicity

Despite wide scale use, there have been few published instances of liver injury due to horse chestnut. In isolated cases of liver toxicity attributed to horse chestnut extracts, injury became apparent between 4 and 8 weeks after starting the herbal and were associated with either hepatocellular or mixed patterns of serum enzyme elevations and with a self-limited, rapidly resolving course. Immunoallergic and autoimmune features were not present or not mentioned.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury attributed to horse chestnut extracts is unknown, but is likely to be idiosyncratic.

### Outcome and Management

Liver injury attributed to horse chestnut use has been relatively mild and self-limited. There have been no instances of acute liver failure, death, chronic hepatitis, cirrhosis or vanishing bile duct syndrome attributed to its use.

Other Names: Aescin, escine, venastat

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Horse Chestnut – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/horsechestnut)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Horse Chestnut | 90045-79-7 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 30 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; horse chestnut is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; horse chestnut is not discussed).
Horse chestnut. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 453-7. (Compilation of short monographs on herbal medications and dietary supplements).
Takegoshi K, Tohyama T, Okuda K, Suzuki K, Ohta G. A case of Venoplant-induced hepatic injury. Gastroenterol Jpn 1986; 21: 62-5. (37 year old man given single intramuscular injection of horse chestnut extract [Venoplant®] for malignant bone fracture developed jaundice 32 days later [bilirubin 2.9 rising to 9.0 mg/dL, ALT 31 rising to 300 U/L, Alk P 2.3 rising to 4 times ULN], positive lymphocyte stimulation test and biopsy showing cholestatic hepatitis 2-3 months after onset, resolving within 6 months of presentation). 3699401
De Smet PA, Van den Eertwegh AJ, Lesterhuis W, Stricker BH. Hepatotoxicity associated with herbal tablets. BMJ 1996; 313: 92. (69 year old woman developed jaundice six weeks after starting herbal tablets [“Venencapsan”] prepared locally from horse chestnut leaf, milfoil, celandine, sweet clover, milk thistle and dandelion root, recurring on reexposure [bilirubin 1.6 and 4.7 mg/dL, ALT 244 and 1004 U/L, Alk P 229 and 250 U/L], resolving rapidly on stopping). 8688761
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig 2008; 100: 688-95. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, including one case due to horse chestnut in a 69 year old woman who developed jaundice 4 weeks after starting the herb [bilirubin 3.8 mg/L, ALT 11.6 times ULN, Alk P normal], resolving in 1 months and considered “definite”). 19159172
Pittler MH, Ernst E. Horse chestnut seed extract for chronic venous insufficiency. Cochrane Database Syst Rev 2012; 11: CD003230. (In 14 studies of horse chestnut therapy for venous insufficiency, 4 studies reported no side effects and the remained mentioned dizziness, gastrointestinal complaints, nausea, headache and pruritus in 1-36% of recipients; no mention of ALT elevations or hepatotoxicity). 23152216
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Review of HDS associated hepatotoxicity; does not mention horse chestnut). 23121117
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to horse chestnut). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were due to horse chestnut: see Navarro [2014]). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Horse Chestnut: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Horse+Chestnut+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Horse Chestnut: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Horse+Chestnut)